# Telithromycin

## OVERVIEW

### Introduction

Telithromycin is a ketolide, a novel form of macrolide antibiotic that is recommended for treatment of community acquired pneumonia. Telithromycin was approved for use in the United States in 2004 and subsequently linked to several cases of severe drug induced liver injury.

### Background

Telithromycin (tel ith" roe mye' sin) is a ketolide antibiotic, a novel form of macrolide antibiotic that is used to treated community acquired pneumonia. Telithromycin differs from erythromycin by several substitutions that render it less susceptible to erythromycin-resistant strains of bacteria. Telithromycin is active against staphylococci, streptococci, S. pneumoniae, Haemophilus spp., Moraxella catarrhalis, mycoplasma, chlamydia and Legionella. Telithromycin was first approved for use in the United States in 2004 and initially had several clinical indications including sinusitis and bronchitis. Currently, because of the potential of serious side effects, the only approved indication for telithromycin is moderate-to-severe community acquired pneumonia due to sensitive organisms. Telithromycin is available in oral forms under the trade name Ketek in tablets of 300 mg (for reduced dosing in patients with renal disease) and 400 mg. The recommended dosage is 800 mg once daily for 7 to 10 days. Telithromycin is generally well tolerated, but side effects can include nausea, abdominal pain, diarrhea, dyspepsia, headache, dizziness and rash.

### Hepatotoxicity

As with other macrolide antibiotics, telithromycin has been associated with a low rate (1% to 2%) of transient serum enzyme elevations during therapy. These elevations, however, are usually transient and resolve even with drug continuation and a similar rate of serum enzyme elevations can occur with comparator agents. More importantly, telithromycin has been linked to severe forms of acute, clinically apparent hepatotoxicity, first reported within a short time of its general approval for use in the United States. The typical latency to onset of liver injury is rapid, some cases presenting within a day or two of initiation of therapy, the average latency being 1 week. The liver injury is often abrupt in onset with fatigue, weakness, jaundice and fever. The pattern of enzyme elevations is typically hepatocellular and serum aminotransferase levels can be quite high (>1000 U/L). Mild and anicteric cases of liver injury attributed to telithromycin have been reported, but some cases are very severe and associated with rapid development of hepatic failure with ascites and hepatic encephalopathy. Eosinophilia and rash can occur, but are not common. Recurrence of injury with reexposure has been described.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatotoxicity from telithromycin is unknown, but the short latency period and abrupt onset of injury suggests hypersensitivity as the cause. Only a proportion of cases have been associated with eosinophilia, and rash, fever, adenopathy and facial edema are rarely described.

### Outcome and Management

Severe cases of liver injury appearing within days of starting telithromycin have been described some of which have been associated with acute and rapid onset of ascites and liver failure requiring liver transplantation. Milder cases of injury and cases without jaundice have generally resolved rapidly over 4 to 6 weeks. Persons with a history of allergy or liver injury due to telithromycin or any macrolide antibiotic such as erythromycin, azithromycin or clarithromycin should not be reexposed to macrolide antibiotics.

Drug Class: Antiinfective Agents, Macrolide Antibiotics

## CASE REPORT

### Case 1. Mild hepatitis after telithromycin therapy.

[Modified from a case in the database of the Drug-Induced Liver Injury Network.]

A 31 year old man was treated with two 5-day courses of telithromycin for sinusitis. Five days after finishing the second course, he developed fever and chills and was found to have abnormal liver tests. On hospital admission, his ALT was 589 U/L but bilirubin was normal (Table). He had no previous history of liver disease or jaundice and drank little alcohol. He took antihistamines and used a nasal spray for his sinusitis, but took no medications chronically and had no drug allergies. Tests for hepatitis A, B and C were negative. Tests for anti-smooth muscle and antinuclear antibodies were weakly positive (1:80). A computed tomography scan of the abdomen showed no evidence of gallstone disease or obstruction. His serum aminotransferases fluctuated and peaked at levels of 15-25 times the upper limit of the normal range, but then gradually declined. Six weeks after admission, he was without symptoms and laboratory tests were completely normal.

#### Key Points

Medication: | Telithromycin (800 mg daily for 5 days)
Pattern: | Hepatocellular (R=43)
Severity: | 1+ (no jaundice)
Latency: | 2 weeks after starting second course
Recovery: | Complete in 6 weeks
Other medications: | Brompheniramine tannate, mometasone nasal spray, rarely acetaminophen

#### Laboratory Values

Time After Starting | Days After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin *(mg/dL) | Other
Second 5-day course of telithromycin (800 mg daily) – 1 week after the first
10 days | 5 days | 589 | 43 | 0.7 | Admission
12 days | 7 days | 1091 | 35 | 1.2 | INR 1.5
15 days | 10 days | 553 | 35 | 0.8 | INR 1.3
19 days | 14 days | 768 | 47 | 1.1
24 days | 19 days | 359 | 59 | 1.1 | Discharge
31 days | 26 days | 151 | 65 | 0.4
2 months | 7 weeks | 36 | 40 | 0.7 | INR 1.0
Normal Values | | <42 | <110 | <1.2

#### Comment

This patient developed anicteric but symptomatic hepatitis within 10 days of starting a second course of oral telithromycin. Worrisome was a slight increase in prothrombin time, but this reversed with time and after vitamin K injections. Serum aminotransferases remained elevated for several weeks, but recovery was complete. The finding of low levels of autoantibodies should lead to further follow up to exclude the possibility of autoimmune hepatitis with an onset marked by episodes of activity, but this is unlikely. The first course of telithromycin may have sensitized this patient; a history of previous exposure to macrolide antibiotics is not uncommon in patients presenting with liver injury. This patient should be strongly warned against future use of telithromycin, the indications for which have now been restricted to community acquired pneumonia. Recommendations regarding other macrolide antibiotics are not as clearly made, but use of a single test dose might be appropriate if these agents are considered necessary.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Telithromycin — Ketek®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=telithromycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Telithromycin | 173838-31-8 | C43-H65-N5-O10 | Telithromycin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2017

Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic induced liver injury; telithromycin was impicated in at least 42 cases of clinically apparent liver injury with four deaths and one liver transplant; clinical features were short latency, abrupt onset and jaundice).
MacDougall C, Chambers HF. Macrolides and ketolides. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1529-34. (Textbook of pharmacology and therapeutics).
Zhanel GG, Walters M, Noreddin A, Vercaigne LM, Wierzbowski A, Embil JM, Gin AS, et al. The ketolides: a critical review. Drugs 2002; 62: 1771-804. (Extensive review of ketolides, macrolides designed to overcome the usual pattern of bacterial resistance to macrolide antibiotics; telithromycin is first member of this class and others are in development; it hs excellent pharmacokinetic properties, but metabolized in liver, interacting with CYP 3A4; clinical trials support efficacy with similar safety profiles as other newer macrolides: diarrhea in 13%, nausea 8%, vomiting 3%, rates of termination 4.8%, no treatment related deaths, ALT elevations in <1% in non-pneumonia cases, <2% with pneumonia and similar rates of elevations as with comparable antibiotics). 12149046
Tellier G, Niederman MS, Nusrat R, Patel M, Lavin B. Clinical and bacteriological efficacy and safety of 5 and 7 day regimens of telithromycin once daily compared with a 10 day regimen of clarithromycin twice daily in patients with mild to moderate community-acquired pneumonia. J Antimicrob Chemother 2004; 54: 515-23. (Clinical trial in 388 patients with community acquired pneumonia found similar rates of efficacy [~90%] and adverse events [~22% mild-to-moderate, possibly related and ~3% severe] with telithromycin as with clarithromycin; no mention of ALT monitoring, hepatitis or liver injury). 15269191
Ciervo CA, Shi J. Pharmacokinetics of telithromycin: application to dosing in the treatment of community-acquired respiratory tract infections. Curr Med Res Opin 2005; 21: 1641-50. (Review of pharmacokinetics of telithromycin, hepatic metabolism 50% largely by CYP 3A4, no discussion of hepatotoxicity). 16238904
Shi J, Montay G, Bhargava VO. Clinical pharmacokinetics of telithromycin, the first ketolide antibacterial. Clin Pharmacokinet 2005; 44: 915-34. (Review of pharmacokinetics of telithromycin; no dose adjustment needed with liver disease, inactions with CYP 3A4, but little effect of grapefruit juice or ketoconazole; rifampin increases plasma levels). 16122280
Clay KD, Hanson JS, Pope SD, Rissmiller RW, Purdum PP 3rd, Banks PM. Brief communication: severe hepatotoxicity of telithromycin: three case reports and literature review. Ann Intern Med 2006; 144: 415-20. Summary for patients in: Ann Intern Med 2006; 144: I42. (Three initial case reports of serious liver injury arising within a few days of starting 5 day courses of telithromycin; 2 men and 1 woman, ages 26-51 years [initial ALT 948, 730 and 2200 U/L, Alk P 291, 188 and 575 U/L and bilirubin 3.8, 9.5 and 13.6 mg/dL] 1 died, 1 underwent liver transplantation and one recovered; histology in two showed massive necrosis; review of published prelicensure trials comparing telithromycin to other antibiotics showed similar rates of ALT elevations during therapy). 16481451
Summaries for patients. Telithromycin: a possible cause of severe liver damage? Ann Intern Med 2006; 144: I42. (Summary of recommendations on telithromycin based upon report of Clay et al [2006]). 16481450
Turner M, Corey GR, Abrutyn E. Telithromycin. Ann Intern Med 2006; 144: 447-8. (Editorial accompanying article by Clay et al [2006] advising caution in using telithromycin). 16549859
Telithromycin: severe hepatitis. Prescrire Int 2006; 15: 139. (Summary of report of Clay et al [2006]). 16991219
Barie PS. A fine pile of paté: the cautionary tale of telithromycin, hepatic failure, and study 3014. Surg Infect (Larchmt) 2006; 7: 247-9. (Editorial summarizing Wall Street Journal investigation on FDA's handling of telithromycin approval). 16875457
Bertino JS. Severe hepatotoxicity of telithromycin. Ann Intern Med 2006; 145: 472; author reply 472. (Letter regarding report of Clay et al. [2006] without new information or data). 16983140
Graham DJ. Telithromycin and acute liver failure. N Engl J Med 2006; 355: 2260-1. (History of FDA approval of telithromycin recounting use of postmarketing databases and European spontaneous reporting of adverse events; estimated from subsequent reporting rates that telithromycin may cause 167 cases of acute liver failure per 1 million person years of use, which is greater than for troglitazone and trovafloxacin, two other agents withdrawn from use because of hepatotoxicity). 17124030
Dore DD, DiBello JR, Lapane KL. Telithromycin use and spontaneous reports of hepatotoxicity. Drug Saf 2007; 30: 697-703. (Analysis of the FDA Adverse Event Reporting System estimating the increased risk of liver injury from telithromycin compared to other medications, demonstrating an 1.82 relative risk of hepatotoxicity compared to other agents, subject to the usual reporting biases). 17696582
Gleason PP, Walters C, Heaton AH, Schafer JA. Telithromycin: the perils of hasty adoption and persistence of off-label prescribing. J Manag Care Pharm 2007; 13: 420-5. (Analysis of data from commercial insurers on secular trends and indications for use of telithromycin; its use increased and overtook clarithromycin within 2 years of its approval, but use fell markedly after FDA warning; only 52% of prescriptions were for listed indications, 4% for pneumonia). 17605513
Curtiss FR. Effective integration of medical and pharmacy claims to better protect patient safety--a long road yet to travel. J Manag Care Pharm 2007; 13: 429-30. (Editorial in response to report by Gleason et al. [2007]). 17605515
Onur O, Guneysel O, Denizbasi A, Celikel C. Acute hepatitis attack after exposure to telithromycin. Clin Ther 2007; 29: 1725-9. (Turkish patient had two episodes of cholestatic jaundice after two exposures to telithromycin one year apart, latency to onset of only 2-3 days, second episode worse, recovery in 4-8 weeks). 17919553
Ross DB. The FDA and the case of Ketek. N Engl J Med 2007; 356: 1601-4. (Editorial on the history of FDA approval of telithromycin describing irregularities that arose in prelicensure studies, controversial reliance on non-inferiority studies, and use of foreign safety data of uncertain reliability). 17442902
Soreth J, Cox E, Kweder S, Jenkins J, Galson S. Ketek--the FDA perspective. N Engl J Med 2007; 356: 1675-6. (FDA response to editorial by Ross [2007] providing history of review of safety concerns, warnings and changes in recommended indications for telithromycin and statement that “..we believe that the potential benefits of Ketek outweigh its risks when it is used according to current approved label…”). 17442912
Brown SD. Benefit-risk assessment of telithromycin in the treatment of community-acquired pneumonia. Drug Saf 2008; 31: 561-75. (Review of benefits and risks of telithromycin concluding that it offers an “acceptable risk ratio in treatment of mild to moderate CAP” [community acquired pneumonia]). 18558790
Shlaes DM, Moellering RC. Telithromycin and the FDA: implications for the future. Lancet Infect Dis 2008; 8: 83-5. (Editorial on decision by FDA to require placebo controlled [rather than comparative agent controlled] trials of new antibiotics for approval of use for acute bacterial sinusitis and acute exacerbation of chronic bronchitis in view of the experience with telithromycin; analyses of the Adverse Event Reporting System showed no excess of reports of hepatitis or cholestasis for telithromycin in comparison to azithromycin, clarithromycin, trovafloxacin or nitrofurantoin; estimated frequency of severe hepatotoxicity to be 1:100,000 to 1:200,000 patients treated). 18222155
Chen Y, Guo JJ, Healy DP, Lin X, Patel NC. Risk of hepatotoxicity associated with the use of telithromycin: a signal detection using data mining algorithms. Ann Pharmacother 2008; 42: 1791-6. (Using a data mining algorithm an excess of reports of hepatotoxicity to the FDA's Adverse Event Reporting System [AERS] was detected between release of telithromycin in early 2004 and the first quarter of 2005; assessed number of reports of hepatotoxicity of all drugs and number reported for telithromycin compared to total numbers of adverse events reported for each). 19033479
Bolesta S, Roslund BP. Elevated hepatic transaminases associated with telithromycin therapy: a case report and literature review. Am J Health Syst Pharm 2008; 65: 37-41. (44 year old man developed mild serum enzyme elevations 3 days after taking telithromycin [800 mg/day] for 3 days [ALT 155 U/L, AST 68 U/L, but normal bilirubin and Alk P]; improved over time, but little follow up given; authors provide a review of the literature on telithromycin). 18159037
Brinker AD, Wassel RT, Lyndly J, Serrano J, Avigan M, Lee WM, Seeff LB. Telithromycin-associated hepatotoxicity: Clinical spectrum and causality assessment of 42 cases. Hepatology 2009; 49: 250-7. (Analysis of 42 cases of hepatotoxicity attributed to telithromycin reported to FDA between 2004-6; 26 were considered probable or highly likely and 16 as only possibly related to telithromycin, many cases were severe including 4 deaths and one liver transplant; onset in 2-43 days [median=10 days] with abrupt onset of symptoms or jaundice, usually hepatocellular with very high ALT, some developing ascites early, resolving with recovery; fever in 29% and eosinophilia in 19%). 19085949
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 5 cases were attributed to telithromycin and 3 to azithromycin as single agents, but none to erythromycin or clarithromycin). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but only one due to macrolides [clarithromycin] and none to telithromycin). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review; the macrolide antibiotics may cause cholestatic hepatitis with jaundice at an estimated rate of 3.6 per 100,000 prescriptions for erythromycin, 3.8 for clarithromycin, and 5.5 cases for telithromycin, compared to 10 for sulfonamides and 2000 for isoniazid). 20107858
Gagne JJ, Glynn RJ, Rassen JA, Walker AM, Daniel GW, Sridhar G, Schneeweiss S. Active safety monitoring of newly marketed medications in a distributed data network: application of a semi-automated monitoring system. Clin Pharmacol Ther 2012; 92: 80-6. (Description of results of a semiautomated, sequential propensity score with a matched cohort approach for drug safety monitoring based upon electronic databases; among 106,658 new users of telithromycin and a similar number of users of azithromycin identified over a 5 year period, 41 cases of hepatitis were found, 23 due to telithromycin for a risk rate of 2 per 10,000 users, not appreciably greater than with azithromycin). 22588606
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributable to telithromycin or other macrolide antibiotics). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to clarithromycin [acute liver failure], but none were attributed to other macrolide antibiotics). 24552865
Ferrajolo C, Coloma PM, Verhamme KM, Schuemie MJ, de Bie S, Gini R, Herings R, et al.; EU-ADR consortium. Signal detection of potentially drug-induced acute liver injury in children using a multi-country healthcare database network. Drug Saf 2014; 37: 99-108. (Analyses of large spontaneous reporting databases from 3 European countries between 1995 and 2010 identified 125 drugs with at least one exposed case of unexplained acute liver injury in children, 20 of which had a statistically significant association, including clarithromycin [5 cases] and erythromycin [4 cases], but no cases were attributed to telithromycin). 24446276
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a nested case control analysis of a health care network database of persons between 2001 and 2009, 8 selected antibiotics were assessed for association with risk of hospitalization for liver injury, adjusted relative risks being significantly elevated for levofloxacin [3.2], moxifloxacin [2.3], doxycycline [2.5], amoxicllin/clavulanate [2.5] and amoxicillin [2.3], but not for clarithromycin [1.8], telithromycin [1.7] or cefuroxime [0.9]). 24865821
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 29 [3.2%] due to marolides of which 18 were linked to azithromycin, 2 to clarithromycin, 2 erythromycin and 7 telithromycin). 25754159
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a health care database of 429,772 children in Italy and the Netherlands followed between 2008 and 2010, 938 cases of liver injury of uncertain cause were identified, the rate being higher in those with current use of antibiotics [12% vs 3.6%] for an adjusted odds rate ratio [aOR] of 3.2; specific antibiotics most commonly implicated were fluoroquinolones [19.0], cephalosporins [4.5], macrolides [3.5] and penicillins [2.6], but no cases were attributed to telithromycin). 28025733
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 2 cases attributed to azithromycin, but none to clarithromycin or other macrolides). 27981596

## OTHER REFERENCE LINKS

1. Recent References on Telithromycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(telithromycin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Telithromycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=telithromycin)